# Larotrectinib

## OVERVIEW

### Introduction

Larotrectinib is a selective inhibitor of neurotrophin receptor kinase (NTRK) that is used in the therapy of solid tumors harboring NTRK gene fusions. Larotrectinib is associated with a high rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Larotrectinib (lar" oh trek' ti nib) is an orally available, small molecule inhibitor of the tropomyosin receptor kinases (TRK-A, -B and -C). The genes of TRK are found to be oncogenic drivers in many solid tumors including gliomas and sarcomas. The tumors harbor a fusion product of the proto-oncogene family and overexpress the neurotrophin receptor kinases which results in abnormal cell growth. Larotrectinib has activity against all three forms of TRK and has been shown to be effective in prolonging progression free survival in children and adults with various solid tumors harboring an NTRK gene fusion. Larotrectinib received accelerated approval for use in the United States in 2018 for the treatment of advanced or metastatic solid tumors that have NTRK gene fusion. Larotrectinib is available in capsules of 25 and 100 mg and as an oral solution of 20 mg/mL under the brand name Vitrakvi. The recommended dose in adults is 100 mg orally twice daily, the dose in children and small adults being adjusted to body surface area. Side effects are common and include fatigue, nausea, vomiting, constipation, diarrhea, dizziness and cough. Uncommon, but potentially serious side effects include neurotoxicity (delirium, dysarthria, dizziness, gait disturbance, tremor), hepatotoxicity (ALT and AST elevations) and embryo-fetal toxicity.

### Hepatotoxicity

In early clinical trials in a total of 176 patients with various forms of solid tumors which had an NTRK gene fusion, elevations in serum aminotransferase levels occurred in 45% of patients treated with larotrectinib. Serum aminotransferase levels rose to above 5 times ULN in 6% of patients and led to early discontinuation in 2%. Serum aminotransferase elevations typically arose after 4 to 12 weeks of treatment, but usually without jaundice or alkaline phosphatase elevations. Most elevations resolved within 4 to 8 weeks and discontinuations were uncommon. Restarting larotrectinib at a reduced dose after resolution of the aminotransferase abnormalities was generally well tolerated and did not lead to recurrence of liver injury. Cases with jaundice and symptoms during larotrectinib therapy have not been reported, but the clinical experience with this kinase inhibitor has been limited and prelicensure clinical trials were carried out with careful clinical monitoring.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury due to larotrectinib is unknown. Larotrectinib is metabolized in the liver largely via CYP 3A4 and is highly susceptible to drug-drug interactions with CYP 3A modulators, such that the dose modifications are recommended if there is concurrent use of CYP 3A inducers (dose increase) or inhibitors (dose decrease by half).

### Outcome and Management

Routine monitoring of liver tests is recommended for patients starting larotrectinib, including serum ALT, AST and bilirubin every 2 weeks for the first month and monthly thereafter and as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal should lead to dose interruption. If changes persist, are severe, or reoccur on restarting, larotrectinib should be discontinued. There have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to larotrectinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Larotrectinib – Vitrakvi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Larotrectinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Larotrectinib | 1223403-58-4 | C21-H22-F2-N6-O2 | Larotrectinib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Abbreviations: NTKR, neurotrophic tyrosine kinase receptor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013, before the availability of larotrectinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/210861Orig1s000_211710Orig1s000MultidisciplineR.pdf (FDA website with the formal review of the safety and efficacy of larotrectinib based upon results in 176 adults and children with solid tumors and NTRK gene fusions, 45% of whom had ALT or AST elevations during therapy, which were above 5 times ULN in 6% and resulted in drug discontinuations in 2%, but no patient developed clinically apparent liver injury with jaundice).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases [6%] were attributed to antineoplastic agents, including 9 due to kinase inhibitors such as imatinib and lapatinib, but none were attributed to larotrectinib). 25754159
DuBois SG, Laetsch TW, Federman N, Turpin BK, Albert CM, Nagasubramanian R, Anderson ME, et al. The use of neoadjuvant larotrectinib in the management of children with locally advanced TRK fusion sarcomas. Cancer 2018; 124: 4241-7. (5 children with advanced refractory sarcomas harboring a NTRK fusion were treated with larotrectinib, and all had an objective response and were able to undergo surgical resection, 3 with a complete response without evidence of recurrence and on no therapy 7-15 months later). 30204247
Ziegler DS, Wong M, Mayoh C, Kumar A, Tsoli M, Mould E, Tyrrell V, et al. Brief report: Potent clinical and radiological response to larotrectinib in TRK fusion-driven high-grade glioma. Br J Cancer 2018; 119: 693-6. (A 3 year old girl with high grade glioma refractory to conventional chemotherapy was found to have a chromosomal translocation resulting in an NTRK3 fusion gene and subsequently had a dramatic clinical and radiological response to larotrectinib therapy with excellent tolerance). 30220707
Landman Y, Ilouze M, Wein S, Neiman V, Yerushalmi R, Yakimov M, Ku N, et al. Rapid response to larotrectinib (LOXO-101) in an adult chemotherapy-naive patients with advanced triple-negative secretory breast cancer expressing ETV6-NTRK3 fusion. Clin Breast Cancer 2018; 18: e267-e270. (37 year old woman with advanced metastatic "triple negative" breast cancer with NTRK3 fusion gene detected in tumor tissue had a dramatic clinical response to larotrectinib therapy). 29233640
Laetsch TW, DuBois SG, Mascarenhas L, Turpin B, Federman N, Albert CM, Nagasubramanian R, et al. Larotrectinib for paediatric solid tumours harbouring NTRK gene fusions: phase 1 results from a multicentre, open-label, phase 1/2 study. Lancet Oncol 2018; 19: 705-14. (Among 24 children or adolescents with advanced or metastatic solid tumors treated with larotrectinib, 14 of 15 with NTRK fusions had an objective response compared to none of those without such mutations, and side effects were mostly mild, ALT or AST elevations occurred in 42% but only one patient required discontinuation because of ALT elevations above 5 times ULN). 29606586
Drilon A, Laetsch TW, Kummar S, DuBois SG, Lassen UN, Demetri GD, Nathenson M, et al. Efficacy of larotrectinib in TRK fusion-positive cancers in adults and children. N Engl J Med 2018; 378: 731-9. (Among 55 children and adults with advanced or metastatic solid tumors harboring TRK fusions treated with larotrectinib, the overall response rate was 75% and adverse events were predominantly mild, with increased ALT or AST in 42%, but values above 5 times ULN in only 7% and no patient had to discontinue therapy because of treatment related adverse events). 29466156

## OTHER REFERENCE LINKS

1. Recent References on Larotrectinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Larotrectinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Larotrectinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Larotrectinib)